# Categorization Of The Likelihood Of Drug Induced Liver Injury

Medications can be categorized for the likelihood that they are associated with drug induced liver injury based upon their known potential for causing such injury. This categorization is important in assessing causality and is based largely upon what has been published in the medical literature. At present there is no accepted classification of drugs based upon this likelihood.

As a part of the ongoing assessment of drug induced liver disease, the Drug-Induced Liver Injury Network (DILIN) Network has developed a five point categorization of the likelihood that a medication is associated with drug induced liver injury. This categorization is largely based upon the published literature and thus is more accurate for drugs that have been extensively used for a prolonged period and is less accurate for more recently approved medications or for drugs and herbals that have not been used widely. These categories are referred to as "Likelihood scores".

Category A .The drug is well known, well described and well reported to cause either direct or idiosyncratic liver injury, and has a characteristic signature; more than 50 cases including case series have been described.

Category B. The drug is reported and known or highly likely to cause idiosyncratic liver injury and has a characteristic signature; between 12 and 50 cases including small case series have been described.

Category C. The drug is probably linked to idiosyncratic liver injury, but has been reported uncommonly and no characteristic signature has been identified; the number of identified cases is less than 12 without significant case series.

Category D. Single case reports have appeared implicating the drug, but fewer than 3 cases have been reported in the literature, no characteristic signature has been identified, and the case reports may not have been very convincing. Thus, the agent can only be said to be a possible hepatotoxin and only a rare cause of liver injury.

Category E. Despite extensive use, no evidence that the drug has caused liver injury. Single case reports may have been published, but they were largely unconvincing. The agent is not believed or is unlikely to cause liver injury.

Category E*. The drug is suspected to be capable of causing liver injury or idiosyncratic acute liver injury but there have been no convincing cases in the medical literature. In some situations cases of acute liver injury have been reported to regulatory agencies or mentioned in large clinical studies of the drug, but the specifics and details supportive of causality assessment are not available. The agent is unproven, but suspected to cause liver injury.

Category X. Finally, for medications recently introduced into or rarely used in clinical medicine, there may be inadequate information on the risks of developing liver injury to place it in any of the five categories, and the category is characterized as “unknown.”

Finally, some agents cause liver injury but only when given in high doses as might occur with a drug overdose. These agents are usually direct toxins. Some do not cause liver injury at normal or therapeutic doses but are quite toxic in overdoses, examples being aspirin, acetaminophen, niacin and vitamin A. These agents are categorized using [HD] after the category of A, B, C or D.

A complete listing of all drugs discussed in LiverTox with their "Likelihood score" is being prepared.